# Clofazimine

## OVERVIEW

### Introduction

Clofazimine is a fat soluble, brick red dye that is used in combination with other agents in the therapy of leprosy. Clofazimine, by itself, has not been associated with serum aminotransferase elevations during therapy or to instances of clinically apparent acute liver injury.

### Background

Clofazimine (kloe faz' i meen) is a fat soluble iminophenazine, brick red dye that has in vitro activity against several species of mycobacteria and was found to be very effective in the treatment of leprosy (Hansen disease). Clofazimine binds to mycobacterial DNA and was developed as a potential therapy of mycobacterium tuberculosis, but showed minimal activity. In contrast, it was found to be a valuable agent in treating leprosy; clinical trials demonstrating benefit both as monotherapy and when combined with dapsone and rifampin. Multidrug therapy using all three agents is now considered the first line of therapy for adults with leprosy and provides a high rate of ultimate cure after 1 to 3 years of therapy. Clofazimine was approved for use in the United States in 1986, but was withdrawn in 2016 and is now only available under the auspices of the National Hansen's Disease (Leprosy) Program (https://www.hrsa.gov/hansens-disease/index.html). In other countries, clofazimine is available under the commercial name Lamprene in tablets of 50 mg, the recommended dose being 100 mg daily. Clofazimine also has immunosuppressive activity and it has been used experimentally to treat discoid lupus erythematosus and psoriasis. More recently, it has shown some activity in treating infectious with drug resistant non-tuberculosis Mycobacterium species including Mycobaterium avian complex and abscessus. The major side effects of clofazimine include skin discoloration and gastrointestinal upset with pain, nausea and diarrhea. The skin discoloration is due to the reddish-orange color of clofazimine and results in a pinkish-brown discoloration of skin and bodily fluids in the majority of patients treated for more than a month. The discoloration fades with stopping the drug, but may persist for months or years. The gastrointestinal side effects of clofazimine can be severe and require dose modification or discontinuation. The symptoms appear to be due to crystallization of the clofazimine molecule in intestinal submucosa; these crystals can also be found in liver, lymph nodes and spleen. While clofazimine is rarely used in the United States, it is an important medication from a worldwide perspective and has played an essential role in public health efforts to eradicate leprosy.

### Hepatotoxicity

Therapy with clofazimine has not been associated with elevations in serum enzymes during treatment and has not been linked to cases of clinically apparent liver injury. The multidrug therapy combination of clofazimine, rifampin and dapsone, however, is associated with instances of jaundice and hepatitis, which are most likely attributable to dapsone ("dapsone syndrome") and marked by fever, rash, eosinophilia and hepatic involvement (DRESS syndrome) typically arising within 8 weeks of starting the drug regimen. Dapsone induced liver injury can be severe and the mortality rate in cases with jaundice is as high as 25% to 33%. The liver injury usually resolves with stopping therapy and most patients have later tolerated restarting of clofazimine and rifampin. Thus, clinically apparent liver injury from clofazimine must be very rare, if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The possible causes of liver injury from clofazimine therapy are not known and might relate to formation of drug-crystals in macrophages in the liver. While crystals of clofazimine can be found in liver and spleen in patients on prolonged therapy, they do not appear to be associated with appreciable liver damage. The hepatic metabolism of clofazimine is not well defined.

### Outcome and Management

The serum aminotransferase and alkaline phosphatase elevations that occur during clofazimine therapy are self-limited and are generally due to other drugs that are used in combination with clofazimine. These abnormalities often resolve even with continuation of clofazimine therapy. Appearance of frank jaundice and hepatitis during multidrug therapy of leprosy should lead to temporary discontinuation of all three medications, but then with careful restarting of clofazimine once the liver injury has resolved.

Drug Class: Antiinfective Agents, Leprosy Agents

Other Drugs in the Subclass, Leprosy Agents: Dapsone , Rifampin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Clofazimine – Lamprene®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Clofazimine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Clofazimine | 2030-63-9 | C27-H22-Cl2-N4 | Clofazimine chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 13 October 2017

Zimmerman HJ. Hepatic injury from the treatment of infectious and parasitic diseases. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. pp 589-637. (Expert review of hepatotoxicity published in 1999, clofazimine is not discussed).
Moseley RH. Antibacterial and Antifungal Agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd Edition. Amsterdam: Elsevier, 2013. p. 463-81. (Review of hepatotoxicity of antibiotics; clofazimine is not discussed).
Gumbo T. Clofazimine. Chemotherapy of tuberculosis, Mycobacterium Avium Complex Disease, and Leprosy. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1560. (Textbook of pharmacology and therapeutics).
Browne SG, Hogerzeil LM. "B 663" in the treatment of leprosy. Preliminary report of a pilot trial. Lepr Rev 1962 Jan; 33: 6-10. (Description of the initial trials of clofazimine in humans with leprosy: 16 patients with lepromatous leprosy were treated with clofazimine [100 to 300 mg daily], some in combination with dapsone, and all 16 improved clinically with no signs of toxicity except for discoloration of the skin and nausea and dizziness in some patients receiving the highest doses). 13873759
Browne SG. Treatment of leprosy with B 633: appraisal of the pilot trial after three years. Lepr Rev 1965 Jan; 36: 13-5. (Among 28 patients with leprosy in Nigeria treated with clofazimine for up to 3 years, all improved clinically and adverse events were ruddy skin and black discoloration without symptoms or itching, resolving upon stopping). 14241912
Clofazimine (Lamprene) in leprosy. Drug Ther Bull 1970; 8: 7-8. (Concise description of clofazimine [a fat soluble, orange dye with both antimycobacterial and antiinflammatory properties], its pharmacology, clinical efficacy in leprosy and safety; no mention of hepatotoxicity). 4903794
Karat AB, Jeevaratnam A, Karat S, Rao PS. Double-blind controlled clinical trial of clofazimine in reactive phases of lepromatous leprosy. Br Med J 1970; 1(5690): 198-200. (Among 24 Indian patients with lepromatous leprosy who were treated for 12 weeks with clofazimine [100 mg three times daily] vs prednisolone, 11 of 12 clofazimine- but only 3 of 12 prednisolone-treated subjects had a clinical response; side effects included red and black pigmentation, but no mention of hepatotoxicity or ALT elevations). 4904935
Helmy HS, Pearson JM, Waters MF. Treatment of moderately severe erythema nodosum leprosum with clofazimine--a controlled trial. Lepr Rev; 42: 167-77. (Among 10 patients with leprosy in Malaysia who developed erythema nodosum leprosum while on dapsone, a 4 week course of clofazimine [300 mg daily] was superior to placebo in inducing clinical improvement; side effects included skin discoloration in most and gastrointestinal intolerance in 30%). 4339652
Schulz EJ. Forty-four months' experience in the treatment of leprosy with clofazimine (Lamprene (Geigy)). Lepr Rev 1971; 42: 178-87. (Among 123 patients with leprosy in South Africa treated with clofazimine with or without dapsone, bacterial clearance and clinical response rates were similar, but erythema nodosum reactions were less with clofazimine; side effects included skin discoloration, pruritus and ichthyosis but liver tests did not change on treatment). 5151819
Karat AB, Jeevaratnam A, Karat S, Rao PS. Controlled clinical trial of clofazimine in untreated lepromatous leprosy. Br Med J 1971; 4 (5786): 514-6. (Among 23 patients with lepromatous leprosy treated with clofazimine [100 mg daily] or dapsone [100 mg daily] for at least 6 months, response rates were similar and serum ALT levels did not change). 4942741
Browne SG. Clofazimine in leprosy. Br Med J 1972; 1 (5798): 506-7. (Letter in response to Karat [1971] commenting that clinical responses cannot be fully assessed with only 6 months of therapy with clofazimine in this small number of patients). 4550304
Mackey JP, Barnes J. Clofazimine in the treatment of discoid lupus erythematosus. Br J Dermatol 1974; 91: 93-6. (Among 26 patients with discoid lupus erythematosus treated with clofazimine, 17 [65%] had a beneficial response and side effects were largely skin pigmentation which faded slowly upon stopping). 4851057
Tolentino JG, Rodriquez JN, Abalos RM. Controlled long-term therapy of leprosy with B663 (lamprene, clofazimine) compared with DDS. Int J Lepr Other Mycobact Dis 1974; 42: 416-418. (Among 43 patients with active leprosy treated with either dapsone or clofazimine, 16 completed 4 years of therapy and all improved clinically regardless of agent used and “no toxic reactions worth mentioning were observed”). 4617720
Ahrens TF, Pettit JH, Ridley DS, Glaus L. Multicentre controlled comparative trial of clofazimine and dapsone in low dosages. Lepr Rev 1975; 46: 287-96. (Among 94 patients with leprosy treated with low doses of either clofazimine [100 mg] or dapsone [50 mg] twice weekly, response rates were similar and erythema nodosum reactions were less with clofazimine [8 vs 24 events]). 1107728
Pattyn SR, Rollier MT, Rollier R, Saerens EJ, Dockx P. A controlled clinical trial of continuous and intermittent rifampicin therapy during an initial three months period in lepromatous leprosy: final analysis. Lepr Rev 1975; 46 (2 Suppl): 129-39. (Among 93 patients with leprosy treated with rifampin [daily or weekly], dapsone and clofazimine, bacterial clearance was fastest with rifampin; jaundice occurred in 1 patient on dapsone). 1100953
Plock H, Leiker DL. A long term trial with clofazimine in reactive lepromatous leprosy. Lepr Rev 1976; 47: 25-34. (Among 17 Tanzanian patients on long term clofazimine [200 to 400 mg daily] for leprosy, 7 discontinued therapy early because of gastrointestinal intolerance). 1263732
Jopling WH. Complications of treatment with clofazimine (Lamprene: B663). Lepr Rev 1976; 47: 1-3. (Editorial on side effects of long term clofazimine therapy focusing upon gastrointestinal discomfort that typically arises several weeks to months after starting and is slow to resolve even upon stopping, associated with reddish-brown discoloration of viscera and crystals of clofazimine in laminal propria of intestines and local lymph nodes). 1263731
Ramu G, Iyer GG. Side effects of clofazimine therapy. Lepr India 1976; 48 (4 Suppl): 722-31. (Among 84 patients with leprosy treated with clofazimine, all developed red or dark skin pigmentation usually within 10 weeks of starting, ichthyosis in 67%, abdominal pain, nausea and diarrhea in 11%, the pain occasionally acute and severe). 1026810
Hastings RC, Jacobson RR, Trautman JR. Long-term clinical toxicity studies with clofazimine (B663) in leprosy. Int J Lepr Other Mycobact Dis 1976; 44: 287-93. (Among 51 patients with leprosy treated with clofazimine for 2-8 years, mild AST elevations occur in 20% of patients, bilirubin levels did not change, and there were no clinically significant toxic effects). 824210
Feldman RA, Sturdivant M. Leprosy in the United States, 1950-1969: an epidemiologic review. South Med J 1976; 69: 970-9. (Over a 20 year period, 1826 cases of leprosy were diagnosed in the US and Puerto Rico, 43% acquired abroad, and most cases reported from Texas, Hawaii and Louisiana). 959886
Jacobson RR, Trautman JR. The diagnosis and treatment of leprosy. South Med J 1976; 69: 979-85. (Overview of the clinical spectrum, diagnosis and therapy of leprosy from the US Public Health Service hospital in Carville, Louisiana discusses use of clofazimine which was an experimental medication at the time and only available from Carville). 959887
Golden GS, McCormick JB, Fraser DW. Leprosy in the United States, 1971-1973. J Infect Dis 1977; 135: 120-5. (Report from the CDC of 419 cases of leprosy diagnosed over a 3 year period in the US, most indigenous cases from California, Texas and Hawaii; 62% lepromatous or dimorphous vs 36% tuberculoid or indeterminate). 833445
Bryceson A. Unnecessary laparotomy for abdominal pain and fever due to clofazimine. Lepr Rev 1979; 50: 258-9. (24 year old man with leprosy treated for 2-3 months with clofazimine [500 mg daily] for corticosteroid resistant erythema nodosum leprosum had severe bouts of abdominal pain that eventually led to laparotomy which showed no abnormalities except for red intraperitoneal fat and black lymph nodes with crystals of clofazimine, the abdominal pains resolving upon stopping drug). 522604
Thomsen K, Rothenborg HW. Clofazimine in the treatment of pyoderma gangrenosum. Arch Dermatol 1979; 115: 851-2. (Among 10 patients with pyoderma gangrenosum treated with clofazimine for 0.5 to 5 months, healing occurred in all patients and tests “of liver and kidney function disclosed no abnormality”). 453894
Browne SG, Harman DJ, Waudby H, McDougall AC. Clofazimine (Lamprene, B663) in the treatment of lepromatous leprosy in the United Kingdom. A 12 year review of 31 cases, 1966-1978. Int J Lepr Other Mycobact Dis 1981; 49: 167-76. (Among 31 patients with leprosy treated in the UK with clofazimine monotherapy for 1-12 years, all had a clinical response and none stopped therapy because of adverse events; 5 patients died, all of unrelated causes). 7196886
Moore VJ. A review of side-effects experienced by patients taking clofazimine. Lepr Rev 1983; 54: 327-35. (Among 65 patients with leprosy treated with clofazimine, 64% developed skin discoloration and 33% had gastrointestinal complaints, but none required stopping). 6668986
Bulakh PM, Kowale CN, Ranade SM, Burte NP, Chandorkar AG. The effect of clofazimine on liver function tests in lepra reaction (ENL). Lepr India 1983; 55: 714-8. (Among 20 patients who developed erythema nodosum reactions while on dapsone for lepromatous leprosy, serum aminotransferase levels were often slightly elevated and levels decreased during clofazimine therapy). 6668931
Pattyn SR, Janssens L, Bourland J, Saylan T, Davies EM, Grillone S, Feracci C. Hepatotoxicity of the combination of rifampin-ethionamide in the treatment of multibacillary leprosy. Int J Lepr Other Mycobact Dis 1984; 52: 1-6. (Among 596 patients with leprosy in the Middle East and Africa treated with regimens using rifampin, prothionamide [or ethionamide] and dapsone [or clofazimine], 81 developed hepatitis within 8 to 186 days which the authors attributed to the combination of rifampin and ethionamide; 1 of 5 patients had recurrence upon rechallenge with the combination). 6368424
Chandorkar AG, Burte NP, Gade RK, Bulakh PM. Once monthly rifampicin (1200 mg) plus daily dapsone (100 mg) and clofazimine (100 mg) in the initial treatment of lepromatous leprosy. Indian J Lepr 1984; 56: 63-70. (Among 30 patients with leprosy who were treated with daily dapsone and clofazimine and monthly rifampin, all had moderate to marked clinical improvement with 6 to 9 months; adverse events included skin pigmentation and renal dysfunction in 2 patients that responded to withdrawal of rifampin). 6384381
Kaluarachchi SI, Fernandopulle BM, Gunawardane BP. Hepatic and haematological adverse reactions associated with the use of multidrug therapy in leprosy--a five year retrospective study. Indian J Lepr 2001; 73: 121-9. (Among 3333 cases of leprosy treated with multidrug therapy between 1991-95, 25 patients had “toxic hepatitis” which was attributed to dapsone). 11579648
Shaw IN, Christian M, Jesudasan K, Kurian N, Rao GS. Effectiveness of multidrug therapy in multibacillary leprosy: a long-term follow-up of 34 multibacillary leprosy patients treated with multidrug regimens till skin smear negativity. Lepr Rev 2003; 74: 141-7. (Among 34 patients with multibacillary leprosy treated with 2 regimens of rifampin, dapsone and clofazimine for 2 years, all responded and none relapsed during mean follow up of 13 years; the only adverse event was reversible skin discoloration attributed to clofazimine). 12862255
Pais AV, Pereira S, Garg I, Stephen J, Antony M, Inchara YK. Intra-abdominal, crystal-storing histiocytosis due to clofazimine in a patient with lepromatous leprosy and concurrent carcinoma of the colon. Lepr Rev 2004; 75: 171-6. (44 year old woman with lepromatous leprosy treated with clofazimine for several years was found to have blackish discoloration of omentum and abdominal lymph nodes and clofazimine crystals in histiocytes during surgery for an unrelated metastatic carcinoma). 15282969
Dacso MM, Jacobson RR, Scollard DM, Stryjewska BM, Prestigiacomo JF. Evaluation of multi-drug therapy for leprosy in the United States using daily rifampin. South Med J 2011 Oct; 104: 689-94. (Review of 158 cases of multibacillary leprosy treated with a multidrug regimen from a U.S. registry [1988-1997], found only one case of relapse, a patient who received a 2-drug regimen [dapsone and daily rifampin] for 2 years). 21941157
Singh H, Nel B, Dey V, Tiwari P, Dulhani N. Adverse effects of multi-drug therapy in leprosy, a two years' experience (2006-2008) in tertiary health care centre in the tribal region of Chhattisgarh State (Bastar, Jagdalpur). Lepr Rev 2011; 82: 17-24. (Among 176 patients treated with multidrug therapy for leprosy in India, 79 [45%] had 84 drug related adverse effects, including 73 from dapsone, 8 rifampin and 16 clofazimine manifested by skin discoloration in 2, gastrointestinal upset in 13 and hematemesis in 3). 21644468
Cholo MC, Steel HC, Fourie PB, Germishuizen WA, Anderson R. Clofazimine: current status and future prospects. J Antimicrob Chemother 2012; 67: 290-8. (Review of the molecular structure, antimicrobial activity, mechanisms of action, pharmacokinetics, adverse effects and antiinflammatory activity of clofazimine). 22020137
Cariello PF, Kwak EJ, Abdel-Massih RC, Silveira FP. Safety and tolerability of clofazimine as salvage therapy for atypical mycobacterial infection in solid organ transplant recipients. Transpl Infect Dis 2015; 17: 111-8. (Among 5 solid organ transplant recipients with mycobacterium avium complex infection who were treated with clofazimine, 2 were cured, 2 died and 1 had gastrointestinal intolerance, side effects included skin discoloration in 3, but “hepatotoxicity was not observed”). 25620390
Talhari C, Talhari S, Penna GO. Clinical aspects of leprosy. Clin Dermatol 2015; 33: 26-37. (Review of the clinical features and diagnosis of leprosy). 25432808
Kar HK, Gupta R. Treatment of leprosy. Clin Dermatol 2015; 33: 55-65. (Review of the current regimens for therapy of leprosy, the first line regimen being dapsone, clofazimine and rifampin given for 6 [pauci-bacillary] or 12 [multi-bacillary] months, now available in blister packs of 4 weeks of treatment). 25432811
Noordeen SK. History of chemotherapy of leprosy. Clin Dermatol 2016; 34: 32-6. (History of the development of therapies for leprosy starting with sulfonamides, and then sulfones such as dapsone, followed by clofazimine and then rifampin, maturing with multidrug therapy using all three for a defined period [1 or 2 years] with monthly rifampin). 26773621
Szeto W, Garcia-Buitrago MT, Abbo L, Rosenblatt JD, Moshiree B, Morris MI. Clofazimine enteropathy: a rare and underrecognized complication of mycobacterial therapy. Open Forum Infect Dis 2016; 3: ofw004. (68 year old woman with lymphoma and hematopoietic cell transplant developed abdominal pain and diarrhea one month after starting clofazimine for Mycobacterium abscessus infection, which was nevertheless continued for 6 months, the pain, diarrhea and weight loss resolving with stopping; no mention of ALT elevations or hepatotoxicity). 27800519
Smith CS, Aerts A, Saunderson P, Kawuma J, Kita E, Virmond M. Multidrug therapy for leprosy: a game changer on the path to elimination. Lancet InfectDis 2017; 17: e293-e7. (Leprosy is still present in 100 low income countries with more than 200,000 cases diagnosed yearly despite multidrug therapy that is highly effective and has been used on 16 million patients supported by long term efforts by WHO, financial support by the Nippon Foundation and donation of the 3 drug combination by Novartis). 28693853
Martiniano SL, Wagner BD, Levin A, Nick JA, Sagel SD, Daley CL. Safety and effectiveness of clofazimine for primary and refractory nontuberculous mycobacterial infection. Chest 2017; 152: 800-9. (Among 117 patients with non-tuberculosis mycobacterial infections who were treated with clofazimine in combination with other agents for a median of 1 year, adverse events included skin rash or discoloration [66%], gastrointestinal complaints [55%] and ALT elevations of greater than 3 times ULN [3%], but no instances of clinically apparent liver injury). 28483608
https://www.hrsa.gov/hansens-disease/index.html (Website for the National Hansen's Disease [Leprosy] Program with information on diagnosis and treatment, including means of obtaining triple therapy).

## OTHER REFERENCE LINKS

1. Recent References on Clofazimine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Clofazimine/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2. Trials on Clofazimine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Clofazimine)